# Caffeine

## OVERVIEW

### Introduction

Caffeine is xanthine alkaloid that occurs naturally in seeds, leaves and fruit of several plants and trees that acts as a natural pesticide. Caffeine is a major component of coffee, tea and chocolate and in humans acts as a central nervous system (CNS) stimulant. Consumption of caffeine, even in high doses, has not been associated with elevations in serum enzyme elevations or instances of clinically apparent liver injury.

### Background

Caffeine is a psychoactive xanthine alkaloid that is a major component of coffee, tea and some foods (chocolate) and is the most frequently used psychoactive agent. At least 90% of adults in the United States consume caffeine daily. Caffeine is also found in several herbs including yerba mate, green coffee beans, guarana berries and yaupon holly. Caffeine is a frequent component of multiingredient dietary supplements, particularly those used for weight loss, improving athletic performance, increasing alertness and decreasing sleepiness. Finally, caffeine is available over-the-counter in tablets generally of 100 or 200 mg for improving alertness and decreasing sleepiness. Caffeine acts as a CNS stimulant, probably by displacing adenosine from A_1_ or A_2_ receptors in the brain. Adenosine in the circulation suppresses neural activity and is believed to be responsible for the feeling of sleepiness via activation of sleep promoting neurons. Reversal of the actions of adenosine may account for the psychoactive characteristics of caffeine containing products. Caffeine has many other actions including inhibition of other neurotransmitters as well as antiinflammatory and immunomodulatory actions. Nevertheless, caffeine is not formally approved as a medication for any condition or disorder. Caffeine is, however, the most commonly used psychoactive drug in the world, largely because of its presence in coffee and tea. The concentration of caffeine in coffee varies greatly by method of preparation and source, but typically ranges from 80 to 175 mg per cup of coffee, and from 20 to 80 mg per cup of tea. The amount in chocolate generally ranges from 10 to 30 mg per bar. Soft drinks also contain caffeine usually in amounts similar to tea. Recently, energy drinks have become popular (Red Bull, Jolt, Monster, and others) which may contain added caffeine in concentrations of 80 to more than 200 mg per can or bottle. Caffeine is a frequent component of multiingredient dietary supplements which may not provide the actual concentrations but are often in the range of 50 to 250 mg per serving. Caffeine in typical amounts is well tolerated and not associated with long term adverse outcomes. In high doses however, generally in excess of 1000 mg daily, caffeine can be toxic. Symptoms include nervousness, irritability, insomnia, headaches, rapid heartbeat, tremor, and gastrointestinal discomfort. Severe toxicity is marked by confusion, excessive anxiety, mania, hallucinations, seizures, rhabdomyolysis, cardiorespiratory arrest and death.

### Hepatotoxicity

Some degree of caffeine intake is almost universal in modern society and an estimated 90% of adults in the United States consume caffeine daily, the average amount being 200 mg daily. Yet despite its widescale use, there is no evidence that regular consumption of caffeine or coffee has adverse effects on the liver. Indeed, epidemiological studies suggest that regular coffee intake may have modest protective effects against the progression of chronic liver disease and development of liver cancer. In high, toxic doses, caffeine can have severe effects on brain, heart and muscle function but has not been linked to clinically apparent liver injury. In contrast, there have been several reports of liver injury linked to use of caffeine rich energy drinks. These reports have not been very convincing and most were not well documented. In many instances, the hepatic injury resembled acute hepatic necrosis or ischemic hepatitis (Case 1). In other cases, other diagnoses were more likely than liver injury from the energy drinks (Case 2). Furthermore, it remains unclear whether the hepatic effects were caused by caffeine per se or to other components in typical energy drinks, such as vitamins, herbs or other botanical products. In reports of caffeine overdose including cases with autopsies, hepatic injury has been absent or not mentioned. Thus, caffeine is unlikely to cause liver injury, but the various high caffeine energy drinks which are widely used may possibly cause liver injury when used to excess.

Likelihood score for caffeine: E (unlikely cause of clinically apparent liver injury).

Likelihood score for energy drinks: C[H] (probable rare cause of clinically apparent liver injury when used in high amounts).

### Mechanism of Injury

Caffeine is metabolized by the microsomal P450 drug metabolizing enzymes, predominantly CYP 1A2. Patients with advanced cirrhosis may have delayed metabolism of caffeine and experience caffeine side effects (nervousness, insomnia, headache) at levels of intake that are well tolerated by patients without liver disease.

Energy drinks typically have high concentrations of caffeine but also a myriad of other components including vitamins, minerals, amino acids, sugar and various herbal products, the concentration and purity of which are usually unknown.

Drug Class: CNS Stimulants, Xanthine Derivatives

Other Drugs in the Class: Theophylline

See also Energy Drinks

## CASE REPORT

### Case 1. Acute liver injury attributed to use of energy drinks.(1)

A 22 year old woman developed low grade fever, abdominal pain, nausea and vomiting and was found to have abnormal liver tests having been consuming 10 cans of energy drinks daily for 2 weeks. On examination in the emergency room, she had epigastric tenderness but no other findings and was sent home. The following day she developed jaundice and was seen again and admitted to the hospital. She denied alcohol or drug abuse and was not taking other medications. Laboratory tests showed marked elevations in ALT and AST (Table) but normal levels of bilirubin, alkaline phosphatase and GGT. The INR was 1.6. Acetaminophen levels were undetectable. There was no serologic evidence of acute hepatis A, B, C or E and tests for Epstein Barr virus and cytomegalovirus infection were negative. She was managed conservatively. She did not undergo liver biopsy or imaging studies. Serum aminotransferase levels decreased rapidly and she was discharged four days later. In follow up one month later, she was asymptomatic and serum ALT levels were normal.

#### Key Points

Medication: | Energy drinks (10 cans daily for 2 weeks)
Pattern: | Hepatocellular (R=~172)
Severity: | 3+ (jaundice and hospitalization)
Latency: | 2 weeks
Recovery: | Within 1 month
Other medications: | None

#### Laboratory Values

Time After Starting | Time After Stopping | ALT (U/L) | AST (U/L) | Alk P (U/L) | Bilirubin (mg/dL) | Other
2 weeks | 0 | 216 | 171 | | 1.7 | Nausea, abdominal pain
| 1 day | 7533 | 7709 | Normal | 3.5 | GGT 29, INR 1.6
| 5 days | 1947 | 238 | | 1.7 | Discharged
| 1 month | 22 | 26
Normal Values | | Not given | | | <1.2

#### Comment

This short report described a young woman who presented with acute hepatic necrosis that was attributed to consumption of energy drinks for two weeks. The marked ALT and AST levels, the R ratio above 100, the abnormality of INR with minimal elevation in bilirubin and the rapid improvement within a week of onset are typical features of acute hepatic necrosis and not typical at all of the acute hepatitis seen with idiosyncratic drug induced liver injury. The clinical presentation was similar to that of acute acetaminophen overdose or acute ischemic hepatitis, both of which might be considered more likely than acute injury from a commercial energy drink. The components of the energy drink that were responsible for the severe acute liver injury were not clear. The product name of the energy drink was not provided but the ingredients listed in the report included vitamins, minerals and an “energy blend” which was likely to include caffeine, but other herbal components were not given.

### Case 2. Acute hepatitis attributed to use of energy drinks.(2)

A 50 year old previously healthy man developed nausea, anorexia, epigastric pain and fatigue followed by dark urine and jaundice and was found to have markedly abnormal liver tests. He reported that he had been drinking 4 to 5 cans of an energy drink for the previous 3 weeks. He denied a history of liver disease, drug allergies, alcohol abuse, injection drug use or risk factors for viral hepatitis. He was not taking other medications or over-the-counter products. Initially, total serum bilirubin was 10.3 mg/dL (direct 7.7), ALT 1203 U/L, AST 1802 U/L, alkaline phosphatase 206 U/L, and INR 1.0. Tests for acute hepatitis A, B and E were negative, but he was positive for both anti-HCV and HCV RNA (5.6 million IU/mL). Antinuclear and smooth muscle antibodies were negative. Ultrasound of the abdomen showed no gallstones or evidence of biliary obstruction. A liver biopsy showed acute hepatitis with bridging necrosis and cholestasis but no fibrosis. Despite the HCV serology, he was diagnosed as having liver injury due to consumption of energy drinks, the suspected ingredient being niacin. After worsening for a few days, he began to improve spontaneously (Table) and in follow up serum weeks later he was asymptomatic and serum aminotransferase levels were normal. Follow up HCV RNA results were not reported.

#### Key Points

Medication: | Energy drinks (4-5 cans daily for 3 weeks)
Pattern: | Hepatocellular (R=~18.8)
Severity: | 3+ (jaundice and hospitalization)
Latency: | 3 weeks
Recovery: | Unclear in timing
Other medications: | None

#### Laboratory Values

Time After Starting | Time After Stopping | ALT (U/L) | AST (U/L) | Alk P (U/L) | Bilirubin (mg/dL) | Other
3 weeks | 1 day | 1203 | 1802 | 206 | 10.3 | Hospitalized
| 2 days | 1112 | 1710 | | 11.5 | Anti-HCV and HCV RNA positive
| 3 days | 1368 | 2435 | | 13.4 | Liver biopsy
| 4 days | 2073 | 4051 | | 19.3
| 5 days | 1629 | 2674 | | 15.7
| 6 days | 1224 | 1695 | | 12.0 | Discharged, asymptomatic
5 weeks | 14 days | 90 | 35 | | 2.7
| 18 days | 23 | 36 | | 2.2
Normal Values | | <38 | <42 | <130 | <1.2

#### Comment

This case report described a 50 year old construction worker who presented with acute hepatitis three weeks after starting regular consumption of energy drinks (4 to 5 cans of an undeclared product daily). Importantly, he also tested positive for anti-HCV and HCV RNA despite having no risk factors for hepatitis C and no previous knowledge of being infected. The authors attributed the acute hepatitis to consumption of the energy drinks and not to hepatitis C, arguing that he more likely had an asymptomatic chronic HCV infection. However, the clinical presentation, liver biopsy findings and subsequent course are entirely compatible with acute hepatitis C. The challenge in this diagnosis is that serologic tests (including IgM anti-HCV) are unreliable in separating acute from chronic infection, and definitive diagnosis acute vs chronic HCV infection depends upon documentation of seroconversion to anti-HCV positivity. The diagnosis can also be fairly reliably made if the infection resolves as the hepatitis resolves, with disappearance of HCV RNA (and rising titers of anti-HCV) or if there is a recent clear history of exposure. Such documentation, however, is not always available and a high proportion of patients with acute hepatitis C develop de novo chronic infection. In large case series, acute hepatitis C accounts for 1 to 5% of cases initially suspected to be drug induced liver injury. Of the six reported cases of acute liver injury from energy drink consumption published between 2000 and 2020, none were very convincing and most had other possible explanations (ischemic hepatitis, liver injury from other drugs being taken, acetaminophen or other toxic overdose).

## PRODUCT INFORMATION

REPRESENTATIVE TRADE NAMES

Caffeine – Generic, NoDoz®

DRUG CLASS

CNS Stimulants, Xanthine Derivatives

COMPLETE LABELING (https://dailymed.nlm.nih.gov/dailymed/search.cfm?labeltype=all&query=caffeine)

Product labeling at DailyMed, National Library of Medicine, NIH

## CHEMICAL FORMULA AND STRUCTURE

DRUG | CAS REGISTRY NUMBER | MOLECULAR FORMULA | STRUCTURE
Caffeine | 58-08-2 | C8-H10-N4-O2

## CITED REFERENCES

1 Vivekanandarajah A, Ni S, Waked A. (2011). Acute hepatitis in a woman following excessive ingestion of an energy drink: a case report. J Med Case Rep.
2 Harb JN, Taylor ZA, Khullar V, Sattari M. (2016). Rare cause of acute hepatitis: a common energy drink. BMJ Case Rep.

## ANNOTATED BIBLIOGRAPHY

References updated: 18 June 2020

Zimmerman HJ. Hepatotoxicity: the adverse effects of drugs and other chemicals on the liver. 2nd ed. Philadelphia: Lippincott, 1999. (Expert review of hepatotoxicity published in 1999; caffeine is not discussed).
O’Brien CP. Caffeine. In, Drug use disorders and addiction. In, Brunton LL, Hilal-Dandan R, Knollmann BC, eds. Goodman & Gilman's the pharmacological basis of therapeutics. 13th ed. New York: McGraw-Hill, 2018, pp. 440. (Textbook of pharmacology and therapeutics).
Benowitz NL, Osterloh J, Goldschlager N, Kaysen G, Pond S, Forhan S. (1982). Massive catecholamine release from caffeine poisoning. JAMA. (30 year old woman took an overdose of caffeine [NoDoz 240 tablets: 24 gm] and developed confusion, emesis, tachycardia, metabolic acidosis and hyperglycemia within hours, resolving with fluid replacement and support within 3 days; liver tests showed “no abnormalities”).
Winek CL, Wahba W, Williams K, Blenko J, Janssen J. (1985). Caffeine fatality: a case report. Forensic Sci Int. (21 year old woman took an overdose of 70 tablets that she thought were amobarbital but actually were mostly caffeine and had a fatal cardiorespiratory arrest, autopsy demonstrating caffeine blood levels of 240 mg/L).
Zimmerman PM, Pulliam J, Schwengels J, MacDonald SE. (1985). Caffeine intoxication: a near fatality. Ann Emerg Med. (37 year old woman took an overdose of 27 gm of caffeine and rapidly developed hypotension, tachycardia, confusion, acidosis and coma [pH 7.2] followed by repeated episodes of ventricular fibrillation, treated successfully with dialysis and medical support [initial caffeine level 199 mg/L] allowing for discharge 27 days later).
Cannon ME, Cooke CT, McCarthy JS. (2001). Caffeine-induced cardiac arrhythmia: an unrecognised danger of healthfood products. Med J Aust. (25 year old woman with known mitral value prolapse had a fatal, witnessed cardiac arrest [ventricular fibrillation] having just consumed a large bottle of an energy drink [Race 2005: 300-570 mg of caffeine]; no mention of hepatic abnormalities).
Holmgren P, Nordén-Pettersson L, Ahlner J. (2004). Caffeine fatalities--four case reports. Forensic Sci Int. (4 patients with fatal caffeine overdoses with lethal levels of caffeine in postmortem blood tests; no description of hepatic effects, although three had known risk factors for liver disease [alcoholism, drug abuse, hepatitis C]).
Ruhl CE, Everhart JE. (2005). Coffee and caffeine consumption reduce the risk of elevated serum alanine aminotransferase activity in the United States. Gastroenterology. (Among 5944 adults evaluated in the US NHANES population based study who had risk factors for liver disease, 8.7% had raised serum ALT levels and increasing levels of coffee consumption and caffeine intake were associated with lower ALT levels suggesting that coffee intake may mitigate liver injury).
Ruhl CE, Everhart JE. (2005). Coffee and tea consumption are associated with a lower incidence of chronic liver disease in the United States. Gastroenterology. (Among 9849 US adults interviewed in 1982-4 and followed in the US NHANES population based study, the risk of death or hospitalization for chronic liver disease was 1.4% overall at 20 years, but was lower in those who drank at least 2 cups of coffee or tea daily [1.1%], vs 1-2 cups [1.6%] or less than 1 cup [1.8%]).
Kerrigan S, Lindsey T. (2005). Fatal caffeine overdose: two case reports. Forensic Sci Int. (Two patients with fatal caffeine overdose, 39 year old woman with known drug use found dead and 29 year old male with obesity, diabetes and known overdose with caffeine pills and vomiting and seizures, had postmortem blood caffeine levels of 192 and 567 mg/L; no mention of liver abnormalities).
Iyadurai SJ, Chung SS. (2007). New-onset seizures in adults: possible association with consumption of popular energy drinks. Epilepsy Behav. (Four adults had new onset seizures accompanied by transient tachycardia and hypertension shortly after consuming energy drinks [Rockstar, Monster], usually on an empty stomach or with diet pills and not recurring during follow up when the energy drinks were stopped; all four had no “laboratory abnormalities” except for high glucose in one).
Muncie HL. (2007). The safety of caffeine consumption. Am Fam Physician. (Discussion of the safety of caffeine in regards to cardiovascular disease, diabetes, renal disease and cancer concludes that patients can safely consume 2-3 cups of coffee or the equivalent amount of caffeine daily).
Haller C, Kearney T, Bent S, Ko R, Benowitz N, Olson K. (2008). Dietary supplement adverse events: report of a one-year poison center surveillance project. J Med Toxicol. (Among 275 poison control center calls about dietary supplements occurring over a 12 month period, 112 [41%] were symptomatic, 8 resulted in hospitalization and one was fatal, the majority of symptomatic cases [47%] were related to a caffeine containing multiingredient products; no mention of hepatotoxicity).
Berger AJ, Alford K. (2009). Cardiac arrest in a young man following excess consumption of caffeinated "energy drinks". Med J Aust. (28 year old man had cardiac arrest [ventricular fibrillation] shortly after consuming 7-8 cans of an energy drink [~640 mg of caffeine] and underwent extensive evaluation including coronary angiography which was normal; no mention of liver test abnormalities).
Higgins JP, Tuttle TD, Higgins CL. (2010). Energy beverages: content and safety. Mayo Clin Proc. (Review of the increasing popularity of energy drinks which often have high levels of caffeine [50-505 mg/serving], but are not regulated in regard to caffeine concentration or claims for performance enhancement; other ingredients may include glucose, taurine, branched chain amino acids, various vitamins, ginseng, guarana, ginkgo, milk thistle, L-carnitine and citric acid).
Reuben A, Koch DG, Lee WM, Acute Liver Failure Study Group. (2010). Drug-induced acute liver failure: results of a U.S. multicenter, prospective study. Hepatology. (Among 1198 patients with acute liver failure enrolled in a US prospective study between 1998 and 2007, 133 were attributed to drug induced liver injury, but none were attributed to caffeine or energy drinks).
Pelchovitz DJ, Goldberger JJ. (2011). Caffeine and cardiac arrhythmias: a review of the evidence. Am J Med. (Caffeine is a nonselective competitive antagonist of adenosine receptor subtypes A_1_ and A_2A_, which in concentrations typically consumed by adults and chronic use [up to 4 cups of coffee daily], has not been associated with excess cardiovascular mortality; there is little evidence that regular use of caffeine is associated with an increased risk of arrhythmias even in high risk subjects).
Vivekanandarajah A, Ni S, Waked A. (2011). Acute hepatitis in a woman following excessive ingestion of an energy drink: a case report. J Med Case Rep. (22 year old woman developed abdominal pain, nausea and vomiting having consumed 10 cans of energy drinks daily for 2 weeks [bilirubin 1.7 rising to 3.5 mg/dL, ALT 216 rising to 7553 U/L, Alk P and GGT normal, INR 1.6], recovering within the next few weeks with no specific therapy: Case 1).
Apestegui CA, Julliard O, Ciccarelli O, Duc DK, Lerut J. (2011). Energy drinks: another red flag for the liver allograft. Liver Transpl. (16 year old man with liver transplant developed sudden rise in liver tests on two occasions one year apart after consuming 3-5 cans of Red Bull daily [ALT 6 and 26 times ULN, bilirubin peak of 2.3 and 10.7 mg/dL], resolving in 4-8 months).
Trabulo D, Marques S, Pedroso E. (2011). Caffeinated energy drink intoxication. BMJ Case Rep. (28 year old man had sudden onset of seizures followed by lactic acidosis, coma and respiratory arrest shortly after drinking several cans of an energy drink [Red Bull] together with coffee, recovering within a week with medical support; no mention of liver test abnormalities although he had a history of injection drug use and hepatitis C).
Babu KM, Zuckerman MD, Cherkes JK, Hack JB. (2011). First-onset seizure after use of an energy drink. Pediatr Emerg Care. (15 year old adolescent boy developed seizures after drinking 2 bottles of “5-hour ENERGY” with emesis and tachycardia [caffeine level 99 mg/L]; he had no further seizures in follow up without anticonvulsant therapy).
Calabrò RS, Italiano D, Gervasi G, Bramanti P. (2012). Single tonic-clonic seizure after energy drink abuse. Epilepsy Behav. (20 year old man had a single seizure having consumed 4-6 cans of Red Bull daily for 5 months and had no further seizures in follow up after stopping energy drink consumption).
Wolk BJ, Ganetsky M, Babu KM. (2012). Toxicity of energy drinks. Curr Opin Pediatr. (Review of the literature on adverse events linked to consumption of energy drinks including cardiovascular [arrhythmias, sudden death], renal [acute renal failure], hepatic [acute hepatitis], neurologic [seizures] and psychiatric effects [anxiety, poor sleep, developmental problems], the ingredients responsible for the adverse events not always being attributable to caffeine).
Sepkowitz KA. (2013). Energy drinks and caffeine-related adverse effects. JAMA. (History of FDA actions in limiting and regulating caffeine containing products, including warning letters concerning energy drinks, mentions that many products do not list the concentration of caffeine and that there may be great individual variation in sensitivity or pharmacodynamics of caffeine which can be affected by underlying liver disease, alcohol use and medications that are metabolized via CYP 1A2).
Noff T, Insel J. (2013). Energy drinks and the unwanted buzz: a case report. Md Med. (46 year old woman with coronary artery disease developed severe chest pain having consumed 3-5 energy drinks daily for 6 months and was found to have abnormal serum aminotransferase levels [bilirubin normal, ALT 325 U/L, AST 437 U/L], which the authors attributed to niacin [30 mg per serving] in the energy drinks; no further details provided).
Consumption of Caffeine in Food and Dietary Supplements; Food and Nutrition Board; Board on Health Sciences Policy; Institute of Medicine. Caffeine in Food and Dietary Supplements: Examining Safety: Workshop Summary. Washington (DC): National Academies Press (US); 2014 Apr 23. (Summary of a workshop on the consumption of caffeine in the United States and evidence for and against cardiovascular and central nervous system safety; no discussion of liver toxicity).
Huang B, Kunkel D, Kabany ME. (2014). Acute liver failure following one year of daily consumption of a sugar-free energy drink. ACG Case Rep J. (36 year old man developed jaundice having consumed 3 energy drinks [Rockstar] daily for a year and having a 15 year history of binge alcohol drinking [bilirubin 16.1 mg/dL, ALT 2995 U/L, Alk P 231 U/L, INR 1.0], with subsequent worsening [bilirubin rising to 23.1 mg/dL, INR 3.7, hepatic encephalopathy] leading to successful liver transplantation).
Gurley BJ, Steelman SC, Thomas SL. (2015). Multi-ingredient, caffeine-containing dietary supplements: history, safety, and efficacy. Clin Ther. (Extensive review of the history, clinical efficacy and safety of multiingredient, caffeine containing dietary supplements which have been widely used as stimulants and weight loss agents and may have greater cardiovascular and neurologic adverse effects because of increase in caffeine toxicity caused by interaction with other components in the supplements such as taurine, p-synephrine, yohimbine, green tea, theanine, dimethylamylamine [DMAA], diethylphenylethylamine [PEA] and, previously, ephedra).
Eichner ER. (2014). Fatal caffeine overdose and other risks from dietary supplements. Curr Sports Med Rep. (Editorial on the dangers including fatalities of unregulated dietary supplements that may contain excessive amounts of caffeine or have toxicities due to contaminants such as amphetamines [Frenzy, Craze] or aegeline [OxyELITE Pro]).
Dickson JC, Liese AD, Lorenzo C, Haffner SM, Watkins SM, Hamren SJ, Stiles JK, et al. (2015). Associations of coffee consumption with markers of liver injury in the insulin resistance atherosclerosis study. BMC Gastroenterol. (Among 1005 nondiabetic patients enrolled in a study of insulin resistance and cardiovascular risk, ALT and AST levels were similar across different average daily coffee intake groups, but were lower in patients with higher intakes of coffee in multivariate analyses controlling for age, sex and ethnicity).
Doepker C, Lieberman HR, Smith AP, Peck JD, El-Sohemy A, Welsh BT. (2016). Caffeine: friend or foe?. Annu Rev Food Sci Technol. (Expert panel review of the risks and benefits of caffeine focusing largely on cardiovascular, reproductive health and behavioral effects).
Harb JN, Taylor ZA, Khullar V, Sattari M. (2016). Rare cause of acute hepatitis: a common energy drink. BMJ Case Rep. (50 year old man developed an acute hepatitis 3 weeks after consuming 4-5 energy drinks daily [bilirubin 10.3 rising to 19.3 mg/dL, ALT 1203 U/L, Alk P 206 U/L, anti-HCV and HCV RNA positive], with rapid resolution on stopping the energy drinks but no information on HCV RNA levels in follow up).
Temple JL, Bernard C, Lipshultz SE, Czachor JD, Westphal JA, Mestre MA. (2017). The safety of ingested caffeine: a comprehensive review. Front Psychiatry. (Review of the safety of caffeine for healthy as well as vulnerable populations concludes that daily intake of up to 400 mg of caffeine is probably safe for healthy adults, but lower levels should be recommended for children and pregnant women).
Higgins JP, Babu K, Deuster PA, Shearer J. (2018). Energy drinks: a contemporary issues paper. Curr Sports Med Rep. (Review of the definition, efficacy and safety of energy drinks which have become increasingly popular, particular among high school and college students, athletes and body builders, and are defined as high caffeine containing beverages that usually contain miscellaneous other components such as vitamins, minerals, amino acids, and herbal products such as ginseng, yohimbe and ginkgo; adverse effects are largely attributable to caffeine and include neurologic and cardiovascular effects, with only rare, isolated reports of liver or kidney injury).
Harty PS, Zabriskie HA, Erickson JL, Molling PE, Kerksick CM, Jagim AR. (2018). Multi-ingredient pre-workout supplements, safety implications, and performance outcomes: a brief review. J Int Soc Sports Nutr. (Review of the efficacy and safety of multiingredient pre-workout supplements which typically contain caffeine, amino acids, nitrates and creatine and are “relatively safe with minimal reported adverse events”, mentions that their use has not been linked to serum enzyme elevations; no discussion of hepatotoxicity or concurrent use of anabolic steroids).
Al Yacoub R, Luczkiewicz D, Kerr C. (2020). Acute kidney injury and hepatitis associated with energy drink consumption: a case report. J Med Case Rep. (62 year old woman with advanced small cell lung cancer in hospice developed nausea, vomiting and confusion and was found to have abnormal liver tests [bilirubin 0.3 mg/dL, ALT 2866 U/L, AST 4333 U/L, Alk P 111 U/L], having had little oral intake for 2 weeks except for 5-6 cans of an energy drink daily).
van Dam RM, Hu FB, Willett WC. (2020). Coffee, caffeine, and health. N Engl J Med. (Review of the metabolism, physiologic and toxic effects of caffeine and coffee consumption including discussion of possible beneficial effects of coffee in chronic liver disease).

## OTHER REFERENCE LINKS

1 Recent References on Caffeine: from PubMed.gov (https://www.ncbi.nlm.nih.gov/sites/entrez?cmd=search&db=pubmed&pubmedfilters=true&term=(Caffeine/AE)+AND+Human%5BMH%5D+AND+(drug+induced+liver+injury+OR+jaundice/CI+OR+bile+duct+diseases/CI+OR+liver/DE+OR+liver+diseases/CI)+AND+(%221900/1/1%22%5BEDat%5D:%222999/12/31%22%5BEDat%5D))
2 Trials on Caffeine: from ClinicalTrials.gov (https://clinicaltrials.gov/ct2/results?term=Caffeine)